# Ripretinib

## OVERVIEW

### Introduction

Ripretinib is a multikinase inhibitor that is used to treat refractory forms of advanced gastrointestinal stromal tumors. Serum aminotransferase elevations occur in a small proportion of patients treated with ripretinib, but episodes of clinically apparent liver injury with jaundice have not been reported with its use.

### Background

Ripretinib (rip re’ tin ib) is an orally available multikinase inhibitor that targets the proto-oncogene KIT and platelet derived growth factor receptor alpha (PDGFRA) and is used to treat patients with advanced and refractory gastrointestinal stromal tumors (GIST) after failure of other therapies. GIST is a rare mesenchymal tumor found most commonly in the stomach and small intestine that varies greatly in aggressiveness from indolent to rapidly progressive. GIST often harbors mutant forms of oncogenes that drive cancer cell proliferation and spread, most commonly KIT (80%) and PDGFRA (5% to 10%). Inhibition of these oncogene receptors can result in marked regression in tumor size. Ripretinib has activity against several other kinases such as PDGFR beta, vascular endothelial growth factor receptor 1 (VEGFR1), TIE2 (angiopoietin receptor), and BRAF, some of which may play a role in the efficacy as well as adverse effects of ripretinib. The first line therapy of GIST is with imatinib which is highly effective, but limited by development of resistant mutations in KIT and other genes which then may require second and third line kinase inhibitors such as sunitinib, nilotinib, regorafenib, bosutinib, ponatinib, or avapritinib. Ripretinib was found to have activity in vitro and in vivo against GIST derived tumor cells with resistant mutations. Ripretinib therapy was subsequently shown to improve progression-free and overall survival in patients with advanced GIST who were refractory to or intolerant of standard kinase inhibitors. Ripretinib was approved in the United States in 2020 as therapy for adults with refractory advanced GIST who have failed therapy with at least 3 standard tyrosine kinase inhibitors. Ripretinib is available in tablets of 50 mg under the brand name Qinlock. The recommended regimen is 150 mg orally once daily until disease progression or unacceptable toxicity. Side effects are common and can include alopecia, fatigue, nausea and vomiting, diarrhea, constipation, decreased appetite, musculoskeletal pain, myelosuppression, and palmar-plantar erythrodysesthesia (hand-foot syndrome). Potent severe adverse events include new onset cutaneous malignancies (including melanoma), photosensitivity, hypertension, cardiac dysfunction, impaired wound healing, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure placebo-controlled clinical trial in patients with refractory and extensively treated GIST, ALT elevations arose in 13% of ripretinib- vs 5% of placebo-treated subjects. ALT elevations were generally transient and mild, and were above 5 times the ULN in only 1% of treated patients and did not require dose modification or discontinuation. Bilirubin elevations were reported in 22% of ripretinib treated patients but only 7.5% of placebo controls. The bilirubin elevations were transient and mild, but were not characterized as to their timing, severity and whether conjugated or unconjugated (direct or indirect). In the open label and controlled trials supporting the approval of ripretinib, there were no instances of clinically apparent liver injury, hepatic failure, or deaths from liver injury. Since its approval in the United States and Europe, there have been no reported cases of clinically apparent liver injury associated with ripretinib therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of liver injury from ripretinib therapy is unknown. While serum bilirubin elevations occurred in more than 20% of patients in preregistration trials, the timing, duration and degree of elevations and whether conjugated or unconjugated were not described. Ripretinib is metabolized in the liver via the cytochrome P450 system, largely CYP3A4 and 2D9. Ripretinib is susceptible to drug-drug interactions with agents that inhibit or induce the CYP 3A4 activity and concurrent use of strong inhibitors of CYP 3A4 should be avoided.

### Outcome and Management

The product label for ripretinib does not recommend routine monitoring of liver laboratory tests during therapy. Serum aminotransferase elevations above 5 times the upper limit of normal (if detected) should lead to dose reduction or temporary cessation of treatment with careful monitoring if restarted after resolution of the abnormalities. Elevations of aminotransferase levels above 20 times ULN and any elevation accompanied by jaundice or symptoms of liver injury should trigger permanent discontinuation of therapy. Cross sensitivity to liver injury is uncommon among the antineoplastic kinase inhibitors, and in preregistration trials, shared liver injury sensitivity between ripretinib and previous administered antineoplastic kinase inhibitors was not found.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Kinase Inhibitor Therapies of GIST: Avapritinib, Bosutinib, Imatinib, Nilotinib, Ponatinib, Regorafenib, Sunitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ripretinib – Qinlock®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ripretinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ripretinib | 1442472-39-0 | C24-H21-Br-F-N5-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 12 October 2023

Abbreviations: SMI, small molecule inhibitor; TKI, tyrosine kinase inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss ripretinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213973Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline clinical review of the safety and efficacy of ripretinib; describes the adverse events observed in a placebo controlled trial with 85 patients receiving ripretinib and 43 placebo, mentioning that at least one adverse event occurred in 99% vs 98%, bilirubin elevations in 17% vs none, and ALT elevations 14% vs 15% which were above 5 times ULN in 1.2% [1 patient] vs none, but no patient developed concurrent ALT elevations and jaundice).
Blay JY, Serrano C, Heinrich MC, Zalcberg J, Bauer S, Gelderblom H, Schöffski P, et al. Ripretinib in patients with advanced gastrointestinal stromal tumours (INVICTUS): a double-blind, randomised, placebo-controlled, phase 3 trial. Lancet Oncol. 2020;21:923-934. (Among 129 adults with advanced GIST with disease progression or intolerance on 3 previous kinase inhibitors treated with ripretinib [150 mg] vs placebo once daily, the median progression free survival was 6.3 vs 1.0 months while adverse event rates included alopecia [59% vs 2%], myalgia [28% vs 9%], fatigue [26% vs 16%], palmar-plantar erythrodysesthesia [21% vs none], and constipation [15% vs 7%]; there was no mention of ALT elevations, and no serious hepatic adverse events). 32511981
Dhillon S. Ripretinib: First approval. Drugs. 2020;80:1133-1138. (Summary of mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of ripretinib shortly after its approval in the US as therapy of advanced, refractory GIST discusses adverse event rates which were 52% vs 5% for alopecia, 42% vs 23% for fatigue, and 21% vs 0% for palmar-plantar erythrodysesthesia; no mention ALT elevations or hepatotoxicity). 32578014
Roskoski R Jr. Properties of FDA-approved small molecule protein kinase inhibitors: A 2021 update. Pharmacol Res. 2021;165:105463. (Extensive review of the human kinases and their approved small molecule inhibitors, their chemical structure, interaction with kinase targets, mechanism of action, clinical efficacy, and clinical indications; mentions that ripretinib is a 4^th^ line therapy for advanced refractory GIST; no mention of adverse events or hepatotoxicity). 33513356
Blay JY, Kang YK, Nishida T, von Mehren M. Gastrointestinal stromal tumours. Nat Rev Dis Primers. 2021;7:22. (Review of the epidemiology, natural history, pathophysiology, activated molecular pathways, molecular subgroups, clinical diagnosis, management, and treatment of GIST). 33737510
Ripretinib (Qinlock) for GIST. Med Lett Drugs Ther. 2021;63(1621):e56-e57. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ripretinib shortly after its approval as therapy of advanced, refractory GIST, discusses its common and its serious adverse effects [skin cancers, hypertension, cardiac dysfunction, impaired wound healing], but does not mention ALT elevations or hepatotoxicity). 33830971
Bauer S, Jones RL, Blay JY, Gelderblom H, George S, Schöffski P, von Mehren M, et al. Ripretinib versus sunitinib in patients with advanced gastrointestinal stromal tumor after treatment with imatinib (INTRIGUE): a randomized, open-label, phase III trial. J Clin Oncol. 2022;40:3918-3928. (Among 453 adults with imatinib-refractory, advanced GIST treated with ripretinib [150 mg daily] or sunitinib [50 mg daily for 4 weeks in 6 week cycles], progression free survival was similar in both groups [8.3 vs 7.0 months] while ripretinib was claimed to be better tolerated; adverse event rates being 99% vs 99%, serious adverse event rates 25.6% vs 25.7%, dose reductions 29% vs 42% and discontinuations 4% vs 8%; no mention of ALT elevations or hepatotoxicity). 35947817
Kumar V, Doros L, Thompson M, Mushti SL, Charlab R, Spehalski EI, Zhao H, et al. FDA approval summary: ripretinib for advanced gastrointestinal stromal tumor. Clin Cancer Res. 2023;29:2020-2024. (Summary of data on efficacy and safety of ripretinib that provided the basis for its FDA approval for use in advanced, refractory GIST mentions adverse events of special interest occurring in the safety population of 351 patients, which included cardiac dysfunction in 1.7%, hypertension in 17%, new primary cutaneous malignancies in 9%, palmar-plantar erythrodysesthesia in 29%, but does not mention ALT elevations or hepatotoxicity ). 36485007
Serrano C, Martín-Broto J, Asencio-Pascual JM, López-Guerrero JA, Rubió-Casadevall J, Bagué S, García-Del-Muro X, et al. 2023 GEIS Guidelines for gastrointestinal stromal tumors. Ther Adv Med Oncol. 2023;15:17588359231192388. (General guidelines on diagnosis, staging, management, and medical therapy of GIST prepared by a multidisciplinary expert panel from the Spanish Group for Sarcoma Research mentions that ripretinib is a 4^th^ line kinase inhibitor generally recommended after failure of imatinib and 2 other conventional kinase inhibitors, and that its toxicity is similar to that of imatinib except for a higher rate of alopecia and palmar-plantar erythrodysesthesia; no mention of ALT elevations or hepatotoxicity). 37655207

## OTHER REFERENCE LINKS

Recent References on Ripretinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ripretinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Ripretinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ripretinib)